# Cyproterone

## OVERVIEW

### Introduction

Cyproterone is a steroidal antiandrogen that has been used in the treatment of prostate cancer in many countries of the world, but not in the United States. Cyproterone therapy can be associated with serum enzyme elevations during therapy and has been linked to many instances of clinically apparent acute liver injury, some of which were fatal.

### Background

Cyproterone (sye pro' ter one) is a synthetic steroidal antiandrogen that has been used to treat prostate cancer in many countries of the world, but was never approved for this use in the United States. Cyproterone is a derivative of hydroxyprogesterone and has mild progesterone-like effects. Its mechanism of action, however, appears to be via blocking of the androgen receptor. Alone or when combined with other agents, cyproterone has been found to be palliative in patients with advanced prostate cancer. Cyproterone has also been evaluated for hormonally sensitive benign conditions such as endometriosis, precocious puberty and infertility, but has not been formally recommended for these uses. Because of its potential to cause liver injury and its inferior efficacy in comparison to other antiandrogens, cyproterone is now rarely used. The typical dose regimen is 50 to 100 mg two to three times daily, often in combination with a gonadotropin releasing hormone agonist such as leuprolide, goserelin, histrelin or triptorelin. Common side effects include hot flashes, sexual dysfunction, nausea, diarrhea, weight change and fluid retention.

### Hepatotoxicity

Cyproterone has been associated with serum enzyme elevations during therapy in 10% to 14% of patients, but these elevations are usually transient and mild and often resolve even without dose modification. More importantly, cyproterone has been associated with many instances of clinically apparent liver injury with jaundice. The time to onset has ranged from a few months to as long as a year, but typically arises within 3 to 6 months of starting treatment. The liver injury is almost always hepatocellular with moderate to marked elevations in serum aminotransferase levels and minimal increases in alkaline phosphatase. Mixed and more cholestatic injury occurs occasionally and may have a more favorable prognosis. Importantly, the hepatocellular injury associated with cyproterone use is often severe and the mortality rate of patients presenting with jaundice is at least 10% (these patients frequently being elderly men with advanced prostate cancer and not qualifying for emergency liver transplantation). Immunoallergic features (fever, rash, eosinophilia) are uncommon, as are autoantibodies. Some patients, however, appear to respond to corticosteroid therapy and rare instances of autoimmune-hepatitis like injury have been attributed to cyproterone. Improvement is usually seen within 1 to 2 weeks of stopping cyproterone and resolution within 1 to 3 months. Nevertheless, many examples of progressive liver injury leading to death from hepatic failure despite prompt discontinuation of therapy have been reported. In rare cases, recovery has been incomplete and patients have had residual evidence of chronic liver disease or cirrhosis.

Likelihood score: B (likely cause of clinically apparent liver injury).

Chronic therapy with cyproterone has also been linked to cases of hepatocellular carcinoma, generally arising after years of therapy with high doses of cyproterone or its combination with other hormonal agents such as estrogens or oral contraceptives. Most cases of hepatocellular carcinoma arose in a noncirrhotic liver and without other evidence of chronic liver injury, although sometimes with elevations in alpha-fetoprotein levels. In some instances, liver cancer was found years after use of cyproterone. The association of cyproterone use with hepatocellular carcinoma remains somewhat controversial.

### Mechanism of Injury

The acute form of liver injury attributed to cyproterone use is probably due to an idiosyncratic reaction to a metabolite of the medication, rather than its antiandrogen or secondary estrogenic effects. The specific mechanism of liver injury caused by cyproterone is not known, but most antiandrogens have hepatotoxicity potential although some to a greater extent than others (cyproterone and flutamide more than bicalutamide and nilutamide).

### Outcome and Management

Cyproterone has been associated with liver injury ranging in severity from asymptomatic or mildly symptomatic elevations in serum enzymes to an acute hepatitis and acute liver failure. At least a dozen instances of fatality from cyproterone acute liver injury have been reported. In some instances, corticosteroids have been used with some evidence of benefit. The most important element is rapid discontinuation of treatment with the first signs of liver injury. Severe and even fatal recurrence of injury upon rechallenge has been reported and restarting of cyproterone after clinically apparent liver injury attributed to its use is inadvisable. Indeed, cross sensitivity to hepatic injury between cyproterone and other antiandrogens (flutamide) has also been reported.

Drug Class: Antineoplastic Agents, Antiandrogens

## CASE REPORT

### Case 1. Severe acute hepatitis causing cirrhosis due to cyproterone.

[Modified from: Abenavoli L, Milic N, Beaugrand M. Severe hepatitis induced by cyproterone acetate: role of corticosteroids. A case report. Ann Hepatol 2013; 12: 152-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/23293208).]

A 66 year old man with advanced prostate cancer developed fatigue and dark urine followed by jaundice approximately 9 months after starting cyproterone (200 mg daily). He had previously undergone prostatectomy and radiotherapy followed by a two year course of bicalutamide and goserelin. Because of evidence of progression, this regimen was switched to cyproterone. He had no previous history of liver disease and was known to have had normal liver tests in the past. He denied a history of alcohol abuse or risk factors for viral hepatitis and was taking no other medications or herbal products. On presentation, he was jaundiced but had no signs of chronic liver disease. Laboratory tests showed a total bilirubin of 22.3 mg/dL, ALT 2044 U/L, AST 1487 U/L, GGT 335 U/L and alkaline phosphatase 223 U/L (Table). The prothrombin index was 43%. Cyproterone was discontinued and he was admitted for evaluation and monitoring. Tests for hepatitis A, B, C and E and for EBV, HSV and CMV were negative. Autoantibodies were not present. Abdominal ultrasound showed increased hepatic echogenicity, but no evidence of biliary obstruction or gallstones. A liver biopsy showed acute hepatocellular injury, portal and periportal inflammation, bridging necrosis and areas of regeneration. He was started on prednisone (60 mg daily) and ursodiol. Serum bilirubin and ALT levels began to decline, but a repeat liver biopsy showed evidence of active cirrhosis. Because of hyperglycemia, the prednisone dose was decreased and then stopped, which was followed by reappearance of jaundice. Prednisone and ursodiol were restarted and he again improved. Thereafter, the dose of prednisone was decreased slowly and ultimately withdrawn. Two years after the initial presentation he was asymptomatic, although liver tests were still slightly abnormal.

#### Key Points

Medication: | Cyproterone (200 mg daily)
Pattern: | Hepatocellular (R=24)
Severity: | 4+ (jaundice, hospitalization, cirrhosis)
Latency: | 9 months
Recovery: | Incomplete
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
9 months | 0 | 2044 | 223 | 22.3 | Cyproterone stopped; Prednisone started
| 1 week | 1655 | 242 | 29.1 | First liver biopsy
10 months | 1 month | ~300 | | | Prednisone 20 mg/day
11 months | 2 months | ~50 | | 0.6 | Second liver biopsy; prednisone stopped
12 months | 3 months | 79 | 288 | 14.1 | Prednisone restarted
14 months | 5 months | ~60 | | ~5.0
18 months | 9 months | ~50 | | 1.7 | Prednisone stopped
24 months | 15 months | ~50 | | 1.7
Normal Values | | <40 | <110 | <1.2

*Some values estimated from Figure 1.

#### Comment

An elderly man developed a severe and protracted hepatitis 9 months after starting cyproterone. He was treated with prednisone and ursodiol, but improvement was slow. An initial attempt to withdraw corticosteroids was unsuccessful, but ultimately he was able to stop treatment. However, a liver biopsy showed cirrhosis and he had mild elevations in liver tests in follow up. Typical of cyproterone hepatotoxicity was the delayed latency, the hepatocellular pattern of injury and severe course. In several reports, corticosteroid therapy was considered to be beneficial, but controlled observations have not been made and remarkable spontaneous recovery can occur.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cyproterone – Generic, Androcur®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cyproterone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cyproterone [INN:BAN] | 2098-66-0 | C22-H27-Cl-O3 | Cyproterone Chemical Structure
17-Hydroxyprogesterone | 68-96-2 | C21-H30-O3 | 17-Hydroxyprogesterone Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 05 July 2017

Zimmerman HJ. Antihypophyseal drugs. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 574-5. (Expert review of hepatotoxicity published in 1999 mentions that cyproterone leads to elevated aminotransferase levels in up to 30% of recipients and also causes acute, clinically apparent hepatocellular injury that can be fatal).
Chitturi S, Farrell GC. Estrogen receptor antagonists. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 612. (Review of hepatotoxicity of hormonal products mentions that liver injury is well recognized with all antiandrogens including cyproterone).
DeLeve LD. Cyproterone acetate. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 558-92. (Review of hepatotoxicity of cancer chemotherapeutic agents mentions that serum enzyme elevations are reported in 10-14% of patients and that 18 case reports of clinically apparent hepatitis attributed to cyproterone have been published with 6 fatalities).
Moy B, Lee RJ, Smith M. Anti-androgens. Natural products in cancer chemotherapy. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1764-7. (Textbook of pharmacology and therapeutics; mentions that cyproterone is a steroidal antiandrogen, but is associated with hepatotoxicity and has inferior efficacy compared to other forms of antiandrogens such as bicalutamide, flutamide and nilutamide).
Meijers WH, Willemse PH, Sleijfer DT, Mulder NH, Grond J. Hepatocellular damage by cyproterone acetate. Eur J Cancer Clin Oncol 1986; 22: 1121-2. (Among 20 women with advanced breast cancer treated with cyproterone [200-400 mg daily], 3 developed minimal ALT [<3 times ULN] and 2 severe ALT elevations [>10 times ULN with mild jaundice], 12 and 21 weeks after starting, resolving within 2 to 3 weeks of stopping). 2946585
Willemse PH, Dikkeschei LD, Mulder NH, van der Ploeg E, Sleijfer DT, de Vries EG. Clinical and endocrine effects of cyproterone acetate in postmenopausal patients with advanced breast cancer. Eur J Cancer Clin Oncol 1988; 24: 417-21. (23 women with breast cancer were treated with cyproterone [200-400 mg daily], of whom 7 [30%] developed serum enzyme elevations, 5 resolving without dose modification, but 2 requiring discontinuation because of hepatitis at 11 and 21 weeks after starting). 2968261
Lévesque H, Trivalle C, Manchon ND, Vinel JP, Moore N, Hémet J, Courtois H, et al. Fulminant hepatitis due to cyproterone acetate. Lancet 1989; 1 (8631): 215-6. (78 year old man developed jaundice 5-6 months after starting cyproterone for prostate cancer [bilirubin 10.4 mg/dL, ALT 1015 U/L, Alk P 153 U/L, prothrombin index 45%], developing ascites and coma; dying 10 days after presentation). 2563116
Blake JC, Sawyerr AM, Dooley JS, Scheuer PJ, McIntyre N. Severe hepatitis caused by cyproterone acetate. Gut 1990; 31: 556-7. (71 year old man with prostate cancer developed weakness 8 weeks after starting cyproterone followed by jaundice after 23 weeks [peak bilirubin 46.2 mg/dL, AST 790 U/L, Alk P 166 U/L], with development of ascites and slow but eventual complete recovery). 2140997
Dore B, Orget J, Irani J, Aubert J. [Hepatitis after treatment with cyproterone acetate. Apropos of a case]. J Urol (Paris) 1990; 96: 169-71. French. (79 year old man developed jaundice 11 weeks after starting cyproterone for prostate cancer [bilirubin 5.2 mg/dL, ALT 856 U/L, Alk P 185 U/L], resolving within 6 weeks of stopping). 2145371
Parys BT, Hamid S, Thomson RG. Severe hepatocellular dysfunction following cyproterone acetate therapy. Br J Urol 1991; 67: 312-3. (3 cases of severe acute hepatocellular injury from cyproterone for prostate cancer; 65, 72 and 83 year old men on treatment for 3-12 months [bilirubin 10.4, 16.4 and 19.1 mg/dL, AST 155, 254 and 377 U/L, Alk P 155, 218 and 252 U/L], resolving with corticosteroid therapy 3 months after stopping in one patient, the other two dying of liver failure 6 and 11 days after presentation). 1827039
Antoni M, Bourlière M, Toullec J, Maillot A, Botta-Fridlund D, Gauthier A. [Fatal subfulminant hepatitis caused by cyproterone acetate]. Gastroenterol Clin Biol 1991; 15: 772-3. French. (80 year old man developed jaundice 6 months after starting cyproterone for prostate cancer [bilirubin 27.7 mg/dL, ALT 20 times ULN, Alk P 1.2 times ULN], dying of hepatic failure one month after presentation). 1840042
Ohri SK, Gaer JA, Keane PF. Hepatocellular carcinoma and treatment with cyproterone acetate. Br J Urol 1991; 67: 213. (75 year old man with prostate cancer developed hepatomegaly 18 months after starting cyproterone [bilirubin 2.5 mg/dL, AST 35 U/L, Alk P 240 U/L], liver biopsy showed hepatocellular carcinoma; no risk factors present). 1848454
Hassler P, Duchêne R. [Hepatotoxicity of cyproterone acetate]. Rev Med Interne 1992; 13: 245. French. (24 year old woman developed abnormal liver tests 3 months after starting cyproterone and estrogens for hirsutism [bilirubin 0.8 mg/dL, ALT 193 U/L, Alk P 594 U/L], resolving within 6 months of stopping both, possibly estrogen related). 1410910
Drakos PE, Gez E, Catane R. Hepatitis due to cyproterone acetate. Eur J Cancer 1992; 28A: 1931-2. (78 year old man developed jaundice 3 months after starting cyproterone and triptorelin for prostate cancer [bilirubin 18.7 mg/dL, ALT 468 U/L, Alk P 246 U/L], resolving within 3 months of stopping cyproterone). 1389539
Roila F, Crinò L, Carloni G, Natalini G. Cyproterone acetate: hepatotoxicity and prostatic cancer treatment. Ann Oncol 1993; 4: 701. (74 year old man developed jaundice 11 months after starting cyproterone and goserelin for prostate cancer [bilirubin 8 mg/dL, ALT 26 times ULN, Alk P "slightly increased"], resolving within 3 months of stopping cyproterone). 8241005
Bressollette L, Dubois A, Carlhant D, Morand C, Mottier D, Riche C. [Fatal hepatitis caused by cyproterone acetate]. Therapie 1994; 49: 153. French. (79 year old man developed jaundice 9 months after starting cyproterone for prostate cancer [bilirubin 30 times ULN, ALT 9 times ULN, Alk P near-normal, prothrombin index 18%], with progressive liver failure and death within 3 days of admission). 7817350
Watababe S, Yamasaki S, Tanal A, Hibi I, Ad hoc committee on Androcur Users, Honna T. Three cases of hepatocellular carcinoma among cyproterone users. Lancet 1994; 344: 1567. (Three girls treated with cyproterone for 3-9 years for short stature or Turner syndrome developed hepatocellular carcinoma despite absence of chronic liver disease or cirrhosis). 7983963
Kattan J, Spatz A, Culine S, Terrier-Lacombe MJ, Elias D, Droz JP. Hepatocellular carcinoma during hormonotherapy for prostatic cancer. Am J Clin Oncol 1994; 17: 390-2. (65 year old man with prostate cancer developed a hepatic mass while on triptorelin and 2 months after a 30 day course of cyproterone [liver tests normal] despite normal CT scan 5 months previously, lobectomy showing hepatocellular carcinoma). 8092108
Hirsch D, Kovatz S, Bernheim J, Shenkman L. Fatal fulminant hepatitis from cyproterone acetate. Isr J Med Sci 1994; 30: 238-40. (92 year old man developed jaundice 4 months after starting cyproterone for prostate cancer [bilirubin 20 mg/dL, ALT 1080 U/L, Alk P 436 U/L, prothrombin index 34%], developing progressive liver failure despite prompt stopping of the drug and corticosteroid therapy, dying 24 days after admission). 8181926
Castellani P, Bernardini D, Renou C, Zamora C, Portal I, Gauthier A, Botta-Fridlund D. [Fatal sub-fulminant hepatitis caused by cyproterone acetate. A new case]. Gastroenterol Clin Biol 1996; 20: 915-6. French. (78 year old man developed jaundice 3 months after starting cyproterone for prostate cancer [bilirubin 25.1 mg/dL, ALT 15 times ULN, Alk P normal, prothrombin index 21%], dying with hepatic failure within 12 days of admission). 8991155
Rüdiger T, Beckmann J, Queisser W. Hepatocellular carcinoma after treatment with cyproterone acetate combined with ethinyloestradiol. Lancet 1995; 345 (8947): 452-3. (45 year old woman developed unexplained hepatomegaly having been on estrogens and cyproterone for 14 years, dying of progressive liver tumor 7 months later). 7853970
Pinganaud G, Chaslerie A, Bourdel Marchasson I, Decamps A, Manciet G, Emeriau JP. Cyproterone-induced hepatotoxicity. Ann Pharmacother 1995; 29: 634. (2 patients with fatal liver injury attributed to cyproterone: 87 and 78 year old men developed fatigue 4 and 12 months after starting cyproterone for prostate cancer [bilirubin 4.9 mg/dL and normal, ALT 100 and 86 U/L, GGT 584 and 252 U/L], both dying 3 weeks later of hepatic failure). 7663042
Murphy BJ, Collins BJ. Severe hepatitis and liver failure induced by cyproterone acetate. Aust N Z J Med 1996; 26: 724. (73 year old man developed jaundice 3 months after starting cyproterone for prostate cancer [bilirubin 11.3 mg/dL, AST 763, Alk P 229 U/L, INR 1.8], developing ascites and bacterial peritonitis, but eventually recovering several months after stopping). 8958378
Rabe T, Feldmann K, Heinemann L, Runnebaum B. Cyproterone acetate: is it hepato- or genotoxic? Drug Saf 1996; 14: 25-38. (Review of the hepatic adverse events of cyproterone; concluded that there was no correlation between the duration of cyproterone use and liver enzyme elevations, but many isolated cases of liver injury have been reported, particularly with the high doses that are used with prostate cancer). 8713486
Hinkel A, Berges RR, Pannek J, Schulze H, Senge T. Cyproterone acetate in the treatment of advanced prostatic cancer: retrospective analysis of liver toxicity in the long-term follow-up of 89 patients. Eur Urol 1996; 30: 464-70. (Among 89 men with prostate cancer treated with cyproterone for up to 12 years, transient liver test abnormalities occurred in 22 [28%], but often from another cause and no patient required drug discontinuation for liver disease or developed clinically apparent liver injury or liver cancer). 8977068
Ruiz-Rebollo ML, Polo F, Palenzuela R, Moretó M [Severe acute hepatitis due to cyproterone]. Gastroenterol Hepatol 1997; 20: 385. Spanish. (64 year old man developed jaundice 6 months after starting cyproterone for prostate cancer [bilirubin 11 mg/dL, ALT 1858 U/L, Alk P normal, prothrombin index 60%], resolving almost completely within 2 months of stopping). 9377242
Lombardi A, Ferrazza P, Castaldi F, Covotta L, Tesoriere A, Urbano V, Midiri G. [Acute hepatic necrosis in a patient treated with cyproterone acetate]. G Chir 1998; 19: 161-3. Italian. (84 year old man developed jaundice after starting cyproterone for prostate cancer [bilirubin 29.5 mg/dL, ALT 746 U/L, Alk P 152 U/L], dying 9 days after presentation). 9628065
Friedman G, Lamoureux E, Sherker AH. Fatal fulminant hepatic failure due to cyproterone acetate. Dig Dis Sci 1999; 44: 1362-3. (Two men [ages 66 and 81 years] with prostate cancer developed jaundice 5 and 6 months after starting cyproterone [bilirubin 12.2 and 30.2 mg/dL, ALT 702 and 395 U/L, Alk P 144 and 376 U/L], with progressive liver failure despite stopping drug promptly, leading to death 36 and 20 days later). 10489919
Pu YS, Liu CM, Kao JH, Chen J, Lai MK. Antiandrogen hepatotoxicity in patients with chronic viral hepatitis. Eur Urol 1999; 36: 293-7. (Among 121 men with prostate cancer who were treated with flutamide or cyproterone 22 [18%] had ALT elevations during therapy, of whom 13 [59%] had either HBsAg or anti-HCV, a higher rate than would be expected, suggesting that hepatotoxicity might be more frequent in patients with hepatitis B or C, although the entire cohort was not tested for viral markers). 10473987
Garty BZ, Dinari G, Gellvan A, Kauli R. Cirrhosis in a child with hypothalamic syndrome and central precocious puberty treated with cyproterone acetate. Eur J Pediatr 1999; 158: 367-70. (Boy with hypothalamic syndrome and precocious puberty was treated with cyproterone from age 5 to 10 and then found to have cirrhosis at age 13 [bilirubin normal, ALT 49 U/L, Alk P normal], dying of sepsis and multiorgan failure one year later). 10333116
Laron Z, Kauli R. Experience with cyproterone acetate in the treatment of precocious puberty. J Pediatr Endocrinol Metab 2000 Jul; 13 Suppl 1: 805-10. (Summary of long term experience using cyproterone in 26 girls with precocious puberty states "we found no alterations in liver function tests, checked routinely"). 10969925
Giordano N, Nardi P, Santacroce C, Geraci S, Gennari C. Acute hepatitis induced by cyproterone acetate. Ann Pharmacother 2001; 35: 1053-5. (87 year old man with prostate cancer developed jaundice 7 months after starting cyproterone [bilirubin 24.4 mg/dL, ALT 484 U/L, Alk P 91 U/L, prothrombin index 61%], resolving within a month of stopping with corticosteroid therapy). 11573856
Lin AD, Chen KK, Lin AT, Chang YH, Wu HH, Kuo JY, Huang WJ, et al. Antiandrogen-associated hepatotoxicity in the management of advanced prostate cancer. J Chin Med Assoc 2003; 66 (12): 735-40. (Retrospective review of 229 patients with prostate cancer treated with flutamide or cyproterone and a GnRH agonist, orchiectomy or radiotherapy with regular monitoring of ALT levels; ALT above 2 times ULN occurred in 15% on flutamide and 9.5% on cyproterone; ALT above 6 times ULN in 5% on flutamide and 4% on cyproterone; no deaths, but a few subjects had jaundice). 15015823
Thole Z, Manso G, Salgueiro E, Revuelta P, Hidalgo A. Hepatotoxicity induced by antiandrogens: a review of the literature. Urol Int 2004; 73: 289-95. (Systematic review of the literature from the Spanish pharmacovigilance group found 21 reports of hepatotoxicity of cyproterone, 46 flutamide, 4 nilutamide and 1 bicalutamide as well as 6 cases of hepatocellular carcinoma linked to cyproterone therapy). 15604569
Manolakopoulos S, Bethanis S, Armonis A, Economou M, Avgerinos A, Tzourmakliotis D. Toxic hepatitis after sequential administration of flutamide and cyproterone acetate. Dig Dis Sci 2004; 49: 462-5. (76 year old man with prostate cancer developed jaundice 6 months after starting flutamide [bilirubin 23.6 mg/dL, ALT 164 U/L, Alk P 132 U/L], which recurred 5 months after switching to cyproterone [bilirubin 6.8 mg/dL, ALT 162 U/L, Alk P 302 U/L], with similar time to recovery). 15139499
Savidou I, Deutsch M, Soultati AS, Koudouras D, Kafiri G, Dourakis SP. Hepatotoxicity induced by cyproterone acetate: a report of three cases. World J Gastroenterol 2006; 12: 7551-5. (3 men, ages 78-83 years, with prostate cancer developed jaundice 3 to 12 months after starting cyproterone [bilirubin 10.1-30 mg/dL, ALT 283-535 U/L, Alk P 300-380 U/L, INR 1.2-2.2]; two had preexisting cirrhosis and one died). 17167851
Manso G, Thole Z, Salgueiro E, Revuelta P, Hidalgo A. Spontaneous reporting of hepatotoxicity associated with antiandrogens: data from the Spanish pharmacovigilance system. Pharmacoepidemiol Drug Saf 2006; 15: 253-9. (Among 508 adverse events reported to the Spanish Pharmacovigilance registry between 1987 and 2004, 114 were for liver injury, 15 due to cyproterone, mean latency 29 weeks, recovery 3.5 weeks, no deaths). 16294367
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports; flutamide ranked 11th with a total of 59 cases, but cyproterone was not among the top 20 listed causes). 16025496
Miquel M, Soler A, Vaqué A, Ojanguren I, Costa J, Planas R. Suspected cross-hepatotoxicity of flutamide and cyproterone acetate. Liver Int 2007; 27: 1144-7. (78 year old man with prostate cancer developed jaundice 3 months after starting flutamide [bilirubin 20.9 mg/dL, ALT 262 U/L, Alk P 104 U/L], resolving upon stopping, but recurring within 2 months of switching to cyproterone [bilirubin 15.6 mg/dL, ALT 373 U/L, Alk P 70 U/L], with similar course of recovery). 17845544
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%2020949552) (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to antiandrogen therapies).
Hsu YC, Tai DI. Unusually high alanine aminotransferase to aspartate aminotransferase ratio in a patient with cyproterone-induced icteric hepatitis. Chang Gung Med J 2011; 34 (6 Suppl): 34-8. (70 year old man developed jaundice 3 months after starting cyproterone for prostate cancer [bilirubin 14 mg/dL, ALT 1311 U/L, AST 82 U/L, protime 15 sec], which recurred within 2 months of reexposure 1 year later [bilirubin 6.2 mg/dL, ALT 399 U/L, AST 268 U/L, Alk P 115 U/L], imaging showing cirrhosis with ascites; death from multiorgan failure one month later). 22490456
Abenavoli L, Milic N, Beaugrand M. Severe hepatitis induced by cyproterone acetate: role of corticosteroids. A case report. Ann Hepatol 2013; 12: 152-5. (66 year old man with prostate cancer developed jaundice 4 months after starting cyproterone [bilirubin 22.3 mg/dL, ALT 2044 U/L, Alk P 223 U/L], with a prolonged course, corticosteroid therapy, but ultimate recovery). 23293208
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to cyproterone). 23419359
Kim JH, Yoo BW, Yang WJ. Hepatic failure induced by cyproterone acetate: A case report and literature review. Can Urol Assoc J 2014; 8 (5-6): E458-61. (87 year old man developed jaundice 3 months after starting cyproterone and a GnRH agonist for prostate cancer [bilirubin 10.6 mg/dL, ALT 223 U/L, GGT 85 U/L, INR 2.4], progressing to hepatic failure and death 20 days after presentation; the authors also summarize results from 15 fatal cases in literature). 25024808
Vodička M, Sálek T, Röderová E, Cerný D. Hepatotoxicity induced by cyproterone acetate in the prostate carcinoma treatment - a case report]. Klin Onkol 2013; 26 (1): 47-8. Czech. (75 year old man with prostate cancer developed jaundice 9 months after starting cyproterone [bilirubin 10.3 mg/dL, ALT 994 U/L, Alk P 193 U/L, GGT 1128 U/L, INR 1.23]). 23528173
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18], nitrofurantoin [n=17], antituberculosis drugs [n=13] and flutamide [n=12: 7%]). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one was attributed to bicalutamide, but none to other antiandrogens such as flutamide, nilutamide and cyproterone). 25754159
Bessone F, Isabel Lucena M, Roma MG, Stephens C, Medina-Cáliz I, Frider B, Tsariktsian G, et al. Cyproterone acetate induces a wide spectrum of acute liver damage including corticosteroid-responsive hepatitis: report of 22 cases. Liver Int 2016; 36 (2): 302-10. (Among 22 cases of cyproterone hepatotoxicity enrolled in Spanish and Latin American Pharmacovigilance Registries [Spain 3, Argentina 17, Uruguay 2] between 1993 and 2013, all were in men with prostate cancer, ages 54 to 83 [mean=70] years, arising 33 to 425 [mean=168] days after starting cyproterone [bilirubin 1.7 to 40 mg/dL, ALT 5.7 to 58.5 times ULN, Alk P 0.2 to 2.9 times ULN]; all except one had jaundice and 3 died; several appeared to benefit from corticosteroid therapy).26104271

## OTHER REFERENCE LINKS

1. Recent References on Cyproterone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Cyproterone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cyproterone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cyproterone)